# Viloxazine

## OVERVIEW

### Introduction

Viloxazine is a selective norepinephrine reuptake inhibitor that is used in the therapy of attention deficit/hyperactivity disorder in children. Viloxazine has been associated with uncommon and mild serum enzyme elevations during therapy but not with occurrence of clinically apparent liver injury.

### Background

Viloxazine (vye lox” a zeen) is a selective norepinephrine reuptake inhibitor (SNRI) that is used to treat pediatric attention deficit/hyperactivity disorder (ADHD). ADHD is marked by variable degrees of inattention, impulsivity and hyperactivity that is inconsistent with developmental levels and that impairs daily life. It is the most common neurodevelopment disorder of children and persists into adulthood in at least 20% of cases. ADHD has major effects on learning and academic achievement as well as social interactions and occupational success. ADHD is reported to affect 9% of children in the United States, and its incidence appears to be increasing. Pharmacologic therapies can alleviate many of the symptoms of ADHD, but are not always well tolerated. Currently approved drugs for ADHD are separated into those that are neurostimulatory (amphetamines, methylphenidate) versus nonstimulatory (such as atomoxetine [an SNRI], viloxazine, guanfacine and clonidine). While viloxazine is considered a norepinephrine reuptake inhibitor, it also has selective serotonergic activity, being a serotonin (5-HT)_2B_ receptor agonist and 5-HT_3C_ receptor antagonist, features that may be important in its beneficial effects. In several randomized placebo-controlled, short term trials in children (ages 6 to 11 years) and adolescents (ages 12 to 17 years), viloxazine was found to improve symptoms of ADHD including inattention and impulsivity/hyperactivity. Viloxazine was approved in the United States as therapy for ADHD in children in 2021. It is available in extended-release capsules of 100, 150 and 200 mg under the brand name Qelbree. For children ages 6 to 11 years, the recommended initial dose is 100 mg once daily which can be increased at weekly intervals to a maximum of 400 mg daily. For children ages 12 to 17 years, the initial dose should be 200 mg once daily, which can be increased to a maximum of 400 mg daily. Side effects can include somnolence, fatigue, decreased appetite, nausea, vomiting, insomnia, irritability, headache and weight loss. Viloxazine can also increase blood pressure and pulse which should be monitored during therapy. Uncommon but potentially severe adverse events include severe somnolence, new onset or recurrence of mania, suicidal ideation and behavior, and embryo-fetal toxicity.

### Hepatotoxicity

In four placebo-controlled trials of viloxazine in children with ADHD, minor serum aminotransferase elevations occurred in 5% to 10% of recipients but were more than 2 times the upper limit of normal in less than 1%. In the preregistration trials, there were no instances of clinically apparent liver injury or serum aminotransferase elevations with jaundice attributable to viloxazine. Since its approval as therapy for depression in Europe more than 30 years ago and as therapy of ADHD in the United States in 2021, there have been no publications describing clinically apparent liver injury due to viloxazine. Furthermore, summaries of the efficacy and safety of viloxazine do not mention hepatic adverse events. Nevertheless, long term clinical experience with viloxazine in children is limited, and other SNRIs (such as atomoxetine) have been linked to rare instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of acute liver injury with jaundice).

### Mechanism of Injury

The mechanism by which viloxazine might cause liver injury is not known but may be due to a toxic or immunogenic intermediate product of its metabolism. Viloxazine is metabolized in the liver largely via the cytochrome P450 system. It is a strong inhibitor CYP 1A2 and weak inducer of CYP 2D6 and 3A4 and is susceptible to drug-drug interactions, particularly with caffeine and theophylline which should be avoided. Viloxazine does not appear to have adverse interactions with methylphenidate.

Drug Class: Central Nervous System Stimulants; ADHD Agents

Other ADHD Agents: Amphetamines, Atomoxetine, Clonidine, Guanfacine, Methylphenidate

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES; Viloxazine – Qelbree®; DRUG CLASS; Drugs for ADHD; COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Viloxazine); Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Viloxazine; HCl | 35604-67-2 | C13-H19-N-O3.Cl-H

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2021

Abbreviations: ADHD, attention deficit/hyperactivity disorder; SNRI, selective norepinephrine reuptake inhibitor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 states that “viloxazine has been mentioned as a cause of jaundice but there are no specific descriptions”).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/211964Orig1s000IntegratedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA integrated review of the viloxazine application for safety and efficacy which mentions that “no clinically meaningful differences in mean laboratory values were observed in viloxazine treated patients as compared to placebo”, and that transient ALT elevations were uncommon [~6% vs 2% with placebo] modest [only 1% were above twice ULN,] and that no cases of drug-induced liver disease were observed).
Pinder RM, Brogden RN, Speight TM, Avery GS. (1977). Viloxazine: a review of its pharmacological properties and therapeutic efficacy in depressive illness. Drugs. (Review of the mechanism of action, clinical efficacy and safety of viloxazine used as an antidepressant in adults, mentions that its clinical efficacy in depression is similar to that of the tricyclic antidepressants, although it may have fewer side effects, the most common being nausea, vomiting and headache; no mention of ALT elevations or hepatotoxicity).
Altamura AC, Mauri MC, Girardi T, Panetta B. (1990). Alcoholism and depression: a placebo controlled study with viloxazine. Int J Clin Pharmacol Res. (Among 30 adults with alcohol dependence and depression treated with viloxazine [400 mg daily] or placebo for 12 weeks, therapy appeared to alleviate symptoms of depression as well as withdrawal symptoms without changes in biochemical evidence of liver injury [ALT, AST and GGT] in comparison to placebo).
Johnson JK, Liranso T, Saylor K, Tulloch G, Adewole T, Schwabe S, Nasser A, et al. (2020). A phase II double-blind, placebo-controlled, efficacy and safety study of SPN-812 (extended-release viloxazine) in children with ADHD. J Atten Disord. (Among 222 children, ages 6 to 12 years, treated with extended release viloxazine [100, 200, 300 or 400 mg] or placebo once daily for 8 weeks, ADHD rating scores improved in viloxazine- compared to placebo-treated children at all doses, while adverse events were greater and partially dose related with viloxazine including somnolence, fatigue, headache, nausea, irritability, and suicidal ideation [4 vs none] and discontinuations [7% vs none], but there were no serious adverse events and “no clinically significant trends in clinical laboratory tests”).
Nasser A, Liranso T, Adewole T, Fry N, Hull JT, Chowdhry F, Busse GD, et al. (2020). A phase III, randomized, placebo-controlled trial to assess the efficacy and safety of once-daily SPN-812 (viloxazine extended-release) in the treatment of attention-deficit/hyperactivity disorder in school-age children. Clin Ther. (Among 460 children, ages 6 to 11 years, with ADHD treated with viloxazine [100 or 200 mg] or placebo daily for 5 weeks, ADHD rating scores improvements and adverse events were more frequent with viloxazine than placebo, and while “no clinical significant trends were found in clinical laboratory results”, transient ALT elevations were recorded in 4% on viloxazine and 3% on placebo).
Cortese S. (2020). Pharmacologic treatment of attention deficit-hyperactivity disorder. N Engl J Med. (Review of the pharmacological therapy of ADHD with discussion of amphetamines, methylphenidate, atomoxetine, guanfacine and clonidine; no mention of ALT elevations during therapy or hepatotoxicity).
Nasser A, Liranso T, Adewole T, Fry N, Hull JT, Chowdhry F, Busse GD, et al. (2021). Once-daily SPN-812 200 and 400 mg in the treatment of ADHD in school-aged children: a phase III randomized, controlled trial. Clin Ther. (Among 313 children, ages 6 to 11 years, with ADHD treated with viloxazine [200 or 400 mg] or placebo once daily for 8 weeks, improvements in ADHD rating scores were greater with viloxazine than placebo [-17.6 and -17.5 vs -11.7] while common adverse events were somnolence [14% vs 1%], decreased appetite [8% vs 0], fatigue [7% vs 5%], headache [7% vs 1%] and abdominal pain [5% vs 2%], which sometimes led to discontinuation, while laboratory test results were largely mild and transient, one child receiving 400 mg of viloxazine had an elevated ALT value [86 U/L]).
Nasser A, Liranso T, Adewole T, Fry N, Hull JT, Busse GD, Chowdhry F, et al. (2021). A phase 3, placebo-controlled trial of once-daily viloxazine extended-release capsules in adolescents with attention-deficit/hyperactivity disorder. J Clin Psychopharmacol. (Among 310 adolescents [ages 12 to 17 years] with ADHD treated with viloxazine [200 or 400 mg] or placebo once daily for 6 weeks, improvements in ADHD rating scores were greater with viloxazine vs placebo [-16.0 and -16.5 vs -11.4], and common adverse events include somnolence, headache, poor appetite, nausea, and fatigue, leading to discontinuations in 2.9% vs none, but no one stopped because of laboratory test results; transient ALT elevations arose in 2 viloxazine treated subjects [1%]).
Nasser A, Liranso T, Adewole T, Fry N, Hull JT, Chowdhry F, Busse GD, et al. (2021). A phase 3 placebo-controlled trial of once-daily 400-mg and 600-mg SPN-812 (viloxazine extended-release) in adolescents with ADHD. Psychopharmacol Bull. (Among 297 adolescents [ages 12 to 17 years] with ADHD treated with viloxazine [400 or 600 mg daily] versus placebo for 7 weeks, ADHD rating scores improved more in the viloxazine arms than placebo [-18.3 and -16.7 vs -13.2] while therapy was considered well tolerated at both doses, common adverse events being somnolence, fatigue, headache, nausea and decreased appetite, with 4.5% discontinuation rate, but none for laboratory abnormalities which included ALT elevations in 10.5% and 10.2% on viloxazine vs none on placebo).
Findling RL, Candler SA, Nasser AF, Schwabe S, Yu C, Garcia-Olivares J, O'Neal W, et al. (2021). Viloxazine in the management of CNS disorders: a historical overview and current status. CNS Drugs. (Review of the history of studies of viloxazine in depression for which it was approved and used in the UK and Europe for over 30 years, with summary of results of previous trials done in adults with depression which reported a favorable safety profile; no mention of ALT elevations or hepatotoxicity).
Viloxazine ER. (2021). (Qelbree) for ADHD. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of viloxazine shortly after its approval for use in the US for ADHD, mentions side effects of somnolence, fatigue, insomnia, anorexia, irritability, nausea, vomiting, headache, weight loss, suicidal ideation and behavior and embryo-fetal toxicity; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Viloxazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Viloxazine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Viloxazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Viloxazine)